# Sunitinib

## OVERVIEW

### Introduction

Sunitinib is multi-specific tyrosine kinase receptor inhibitor that is used in the therapy of gastrointestinal stromal tumors and advanced renal cell carcinoma. Sunitinib therapy is associated with transient elevations in serum aminotransferase and bilirubin levels and rare instances of clinically apparent acute liver injury.

### Background

Sunitinib (soo ni' ti nib) is an inhibitor of several tyrosine kinase receptors which are associated with tumor growth and angiogenesis. The tyrosine kinase receptors of cancer cells are often mutated and can cause unregulated cell growth and proliferation. Sunitinib is one of several tyrosine kinase receptor inhibitors that have been introduced into cancer chemotherapy and are specially directed at molecular abnormalities that occur in cancer cells. Inhibition of the receptor can lead to dramatic reversal of progression the cancer, although sometimes limited by the development of tumor resistance caused by mutations in the kinase. Sunitinib has special activity against the abnormal tyrosine kinase (cKit) that is found in gastrointestinal stromal tumors (GIST). Sunitinib also has activity against the receptors for platelet derived growth factor (PDGF) and vascular endothelial growth factor (VEGF). Sunitinib received approval for use in the United States in 2006. Current indications are for unresectable or metastatic GIST with positive cKit (CD117), advanced renal cell carcinoma and advanced pancreatic neuroendocrine tumors. Sunitinib is also used in patients who are intolerant or become resistant to imatinib, the initial tyrosine kinase receptor inhibitor that has special activity against chronic myelogenous leukemia (CML) bearing the Philadelphia chromosome. Sunitinib is available in capsules of 12.5, 25 and 50 mg under the brand name Sutent. The typical dose of sunitinib is in cycles of 4 weeks, followed by a rest period of 2 weeks, using a starting dose of 37.5 or 50 mg daily and increasing or decreasing in 12.5 mg increments, with each cycle based upon tolerance and response. Side effects include fatigue, diarrhea, anorexia, skin discoloration, rash, hand-foot syndrome, edema, muscle cramps, arthralgias, headache, abdominal discomfort, anemia, cough, and pruritus. Uncommon side effects include heart failure, pancreatitis and renal failure.

### Hepatotoxicity

In large clinical trials of sunitinib, elevations in serum aminotransferase levels were common, occurring in 39% of sunitinib vs 23% of placebo recipients. Values greater than 5 times the upper limit of normal (ULN) occurred in only 2% to 3% of sunitinib recipients (and 1% of controls). These abnormalities were usually asymptomatic. Dose adjustment or temporary discontinuation and restarting at a lower dose is recommended if enzyme levels are markedly elevated (ALT or AST persistently greater than 5 times ULN or bilirubin more than 3 times ULN). Sunitinib therapy is also associated with a high rate of serum bilirubin elevations, generally in the mild-to-moderate range and not in association with ALT or AST elevations. These changes are probably due to interaction with hepatic UDP-glucuronyltransferase, the enzyme that is also responsible for bilirubin excretion.

More importantly, there have been several case reports of clinically apparent liver injury attributed to sunitinib therapy. The time to onset was after several cycles of therapy. The pattern of serum enzyme elevations was typically hepatocellular and the clinical presentation resembled acute hepatic necrosis. In some instances, the injury may have been due to hypotension, shock or ischemia rather than direct hepatotoxicity (Case 1). Regardless, the injury can be severe and several instances of acute liver failure and death have been reported. Immunoallergic features (rash, fever and eosinophilia) are not common.

Finally, sunitinib has also been reported to cause hyperammonemia and encephalopathy in rare patients with cancer treated with conventional or even low oral doses (Case 2). The time to onset was within 1 to 3 weeks, presenting with confusion and irritability with minimal elevations in serum enzymes and bilirubin and marked increases (4-10 times the ULN) in serum ammonia. Recovery is rapid once sunitinib is stopped and the syndrome can recur with re-exposure. Interesting, there appears to be little cross-reactivity to this complication with other tyrosine kinase inhibitors.

Likelihood score: B (highly likely cause of clinically apparent liver injury, including hyperammonemic syndrome).

### Mechanism of Injury

The clinical features of cases of severe acute liver injury due to sunitinib have suggested ischemic damage that may be related to hypotension and anoxia, rather than direct hepatic injury. Sunitinib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic intermediate. The cause of hyperammonemia due to sunitinib is unknown, but it appears to be idiosyncratic and may relate to inhibition of urea cycle enzymes by sunitinib.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. In some situations, therapy can be restarted particularly with concurrent prednisone (10-20 mg daily). In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. There does not appear to be cross reactivity in risk for hepatic injury between sunitinib and other tyrosine kinase inhibitors and, in some situations, switching to another tyrosine kinase receptor inhibitor may be appropriate. Cases of acute liver failure have occurred in patients receiving sunitinib. In using this medication, other potentially hepatotoxic agents should be avoided.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## CASE REPORTS

### Case 1. Severe acute liver injury during sunitinib therapy.

[Modified from: Mueller EW, Rockey ML, Rashkin MC. Sunitinib-related fulminant hepatic failure: case report and review of the literature. Pharmacotherapy 2008; 28: 1066-70. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18657022)]

A 75 year old woman with metastatic renal cell carcinoma developed severe diarrhea and dehydration after a fifth 4-week cycle of sunitinib and was found to be jaundiced. Her renal carcinoma had been diagnosed six months earlier, at which time she had undergone right nephrectomy. Metastases were identified in the inferior vena cava and lungs and she was started on sunitinib in 4 week courses, followed by a rest period of 2 weeks. She had multiple side effects with chemotherapy including fatigue, arthralgias, dry mouth, thrombocytopenia, neutropenia, abdominal pain and diarrhea. Her liver tests were known to be normal before and during the first five cycles of sunitinib therapy (Table). Four days after the fifth cycle, she was brought to the hospital by her family because of dehydration and mental confusion following a 3 day history of diarrhea. She had no known liver disease, alcohol use or risk factors for viral hepatitis. Her past medical history included breast cancer treated with lumpectomy 7 years earlier as well as hypothyroidism, hypertension, chronic heart failure, gastroesophageal reflux disease, bladder surgery and carpal tunnel syndrome. Her other medications included letrozole, alendronate, irbesartan, docusate sodium, prochlorperazine, clonidine, lansoprazole, filgrastim and levothyroxine. On admission, she was tachypneic, but other vital signs were normal. Liver tests showed elevations in serum bilirubin (5.9 mg/dL) with marked elevations in serum aminotransferase levels (ALT 3332 U/L, AST 3872 U/L) and creatine kinase (21,729 U/L), with prolongation of the prothrombin time (INR 4.8) and elevation in serum ammonia (897 μg/dL). Serum blood urea nitrogen and creatinine were also elevated (84 and 2.7 mg/dL). Tests for hepatitis A, B and C were negative. Abdominal ultrasound showed no evidence of biliary obstruction. She was treated for suspected acute liver failure. With conservative medical management she began to improve, her mental status returning to normal within a few days and serum aminotransferase levels falling rapidly (Table). She was discharged after 7 days in the hospital and had normal liver tests when tested 1 month later.

#### Key Points

Medication: | Sunitinib (50 mg daily in 5 4-week cycles)
Pattern: | Hepatocellular (R=unable to calculate, no alkaline phosphatase results)
Severity: | 4+ (jaundice, hospitalization and features of hepatic failure)
Latency: | ~9 months
Recovery: | 1 month
Other medications: | Stable doses of letrozole, alendronate, irbesartan, docusate sodium, prochlorperazine, clonidine, lansoprazole, filgrastim and levothyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | CPK (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 31-36 | | 0.4-0.7 | Values before and during five cycles
| | Admitted for severe diarrhea and dehydration
9 months | 4 days | 3332 | 21,729 | 5.9 | INR 4.8, Ammonia 897 μg/dL
| 5 days | 2534 | 9981 | 6.4
| 6 days | 2234 | 5824 | 6.4
| 7 days | 1632 | | 7.0 | INR 1.7, Ammonia 85 μg/dL
| 8 days | 1060 | 656 | 5.9
| 9 days | 618 | 329 | 4.6
| 10 days | 465 | 198 | 4.6 | INR 1.4
10 months | 1 month | 21 | | 0.6
15 months | 6 months | 33 | | 0.5
Normal Values | | <40 | <250 | <1.2

#### Comment

While the patient was considered to have acute liver failure due to sunitinib induced liver injury, a more likely cause was acute ischemia or shock causing centrolobular acute hepatic necrosis and attendant liver failure, coagulopathy and confusion. The clinical phenotype of the presentation and course was that of acute hepatic necrosis, with rapid rise and rapid fall in serum aminotransferase levels, accompanied with increase in creatine kinase and early appearance of coagulopathy, encephalopathy and renal dysfunction. Acute liver failure due to medications typically has a more insidious onset with hepatic failure arising in the setting of deep jaundice and recovery being slow and protracted. While sunitinib therapy is associated with a high rate of minor serum aminotransferase elevations (in up to 61%), these abnormalities are rarely severe (~2%), and are usually asymptomatic and rapidly resolve either spontaneously or with dose adjustment.

### Case 2. Hyperammonemia and coma during sunitinib therapy.

[Modified from case 2 in: Lee NR, Yhim HY, Yim CY, Kwak JY, Song EK. Sunitinib-induced hyperammonemic encephalopathy in gastrointestinal stromal tumors. Ann Pharmacother 2011; 45: e56. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21954449)]

A 68 year old woman with metastatic gastrointestinal stomal tumors (GIST) of the cecum developed confusion and irritability 10 days after starting sunitinib (50 mg daily) and required emergency hospitalization. She had been treated with imatinib for 3 years, but had developed disease progression despite dose increases. She had no history of liver disease or risk factors for viral hepatitis and denied taking other medications except for lansoprazole (30 mg daily) and tramadol (40 mg daily). Laboratory tests showed minimal elevations in serum ALT (53 U/L) and AST (44 U/L) with normal serum bilirubin (0.7 mg/dL), but marked elevations in serum ammonia (Table). CT scans of the brain showed no abnormalities. Sunitinib was stopped and she was treated with hypdration and lactulose. She improved rapidly with ammonia levels decreasing within 24 hours and she was discharged four days later. However, she presented with a similar severe episode of confusion within a week, having restarted sunitinib immediately after discharge. Again she improved within 24 hours of stopping sunitinib for the second time and was discharged 4 days later. She did not restart sunitinib and had no further episodes of hyperammonemia.

#### Key Points

Medication: | Sunitinib (50 mg daily of 10 days)
Pattern: | Minimal enzyme elevations
Severity: | 4+ (encephalopathy)
Latency: | 10 days initially, 7 days on re-exposure
Recovery: | 4 days
Other medications: | Lansoprazole and tramadol

#### Laboratory Values

Time After Starting | Time After Stopping | Ammonia (μg/dL) | Bilirubin (mg/dL) | Other
Pre | Pre | | 0.4 | No known liver disease
0 | Sunitinib (50 mg daily) started for metastatic GIST
10 days | 0 | 389 | 1.7 | Admission for confusion
11 days | 1 | 116 | 1.7 | Clinically improved
14 days | 4 days | Discharged and sunitinib restarted
21 (7) days | 11 (0) days | 210 | 1.5 | Re-admitted for confusion
(8) days | (1) day | 59 | 1.5
(11) days | (4) days | Discharged
Normal Values | | <45 | <1.2

*Values parenthesis represent days after restarting or restopping sunitinib.

#### Comment

Hyperammonemic coma is a rare but distinctive syndrome that has been linked to therapy with valproic acid and with various cancer chemotherapeutic regimens. Patients are typically dehydrated and present with irritability, stupor and confusion progressing to frank coma. Routine liver tests are usually normal or minimally abnormal, but ammonia levels are high. The syndrome reverses rapidly once the causative medication is stopped, but it can be severe and fatalities have been reported. The cause of the syndrome is not known, but probably relates to inhibition of mitochondrial or urea cycle enzyme function rather than frank hepatic failure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sunitinib – Sutent®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sunitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sunitinib | 557795-19-4 | C22-H27-F-N4-O2 | Sunitinib Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 27 June 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors such as sunitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published; erlotinib has been linked to several cases of clinically apparent liver injury, 2 of which were fatal).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Deeks ED, Keating GM. Sunitinib. Drugs 2006; 66: 2255-66; discussion 2267-8. (Review of structure, pharmacology, mechanism of action, clinical efficacy and safety of sunitinib; no mention of hepatotoxicity or ALT elevations during therapy). 17137406
Adams VR, Leggas M. Sunitinib malate for the treatment of metastatic renal cell carcinoma and gastrointestinal stromal tumors. Clin Ther 2007; 29: 1338-53. (Systematic review of the literature of clinical efficacy and tolerability of sunitinib; ALT or AST elevations occurred in 39% of sunitinib vs 23% of placebo recipients, values >5 times ULN in 2% vs 1% and bilirubin elevations in 16% vs 8%). 17825686
Goodman VL, Rock EP, Dagher R, Ramchandani RP, Abraham S, Gobburu JV, Booth BP, et al. Approval summary: sunitinib for the treatment of imatinib refractory or intolerant gastrointestinal stromal tumors and advanced renal cell carcinoma. Clin Cancer Res 2007; 13: 1367-73. (Summary of the FDA review of sunitinib in support of its approval in the United States; ALT or AST elevations occurred in 39% of sunitinib and 23% of placebo recipients and were greater than 5 times ULN in 2% vs 1%; no mention of clinically apparent liver injury). 17332278
Mueller EW, Rockey ML, Rashkin MC. Sunitinib-related fulminant hepatic failure: case report and review of the literature. Pharmacotherapy 2008; 28: 1066-70. (75 year old woman with metastatic renal cancer developed diarrhea and dehydration after a fifth cycle of sunitinib and was found to be jaundiced on admission [bilirubin 5.9 mg/dL, ALT 3332 U/L, INR 4.8] with hepatic failure, but rapid clinical improvement and resolution within the next 6 months: Case 1). 18657022
Gore ME, Szczylik C, Porta C, Bracarda S, Bjarnason GA, Oudard S, Hariharan S, et al. Safety and efficacy of sunitinib for metastatic renal-cell carcinoma: an expanded-access trial. Lancet Oncol 2009; 10: 757-63. (Summary of results from expanded access to sunitinib for renal cell carcinoma in 4564 patients enrolled in 52 countries; common side effects were fatigue and diarrhea, nausea, stomatitis, anorexia, hand-foot syndrome, hypertension and dyspepsia; rates of serum ALT elevations not reported, but among 63 [1.4%] deaths attributed to treatment related adverse events, 4 [0.1%] were due to hepatic failure; no details given). 19615940
Weise AM, Liu CY, Shields AF. Fatal liver failure in a patient on acetaminophen treated with sunitinib malate and levothyroxine. Ann Pharmacother 2009; 43: 761-6. (57 year old woman with metastatic gastrointestinal stromal tumors resistant to imatinib therapy developed jaundice on day 4 of a 9th cycle of sunitinib [bilirubin 2.8 mg/dL, ALT 1588 U/L, Alk P 81 U/L, INR 2.17], with progressive liver failure and death 4 days later, autopsy showing marked centrolobular necrosis). 19336648
Gomez-Abuin G, Karam AA, Mezzadri NA, Bas CA. Acalculous cholecystitis in a patient with metastatic renal cell carcinoma treated with sunitinib. Clin Genitourin Cancer 2009; 7: 62-3. (62 year old woman with metastatic renal carcinoma developed acute acalculous cholecystitis during 4th week of first cycle of sunitinib [bilirubin "slightly" increased, ALT and Alk P values not given], resolving with conservative management, and the patient was able to restart sunitinib without recurrence). 19213671
O'Reilly EM, Niedzwiecki D, Hall M, Hollis D, Bekaii-Saab T, Pluard T, Douglas K, et al; Cancer and Leukemia Group B. A Cancer and Leukemia Group B phase II study of sunitinib malate in patients with previously treated metastatic pancreatic adenocarcinoma (CALGB 80603). Oncologist 2010; 15: 1310-9. (Trial of sunitinib in 77 patients with previously treated metastatic pancreatic cancer found median survival of less than 4 months and toxicity to be common; ALT or AST elevations occurred in 7%, but there was no mention of clinically apparent liver injury). 21148613
Matsumoto K, Sawaki A, Mizuno N, Hara K, Hijioka S, Niwa Y, Tajika M, et al. Clinical efficacy and safety of sunitinib after imatinib failure in Japanese patients with gastrointestinal stromal tumor. Jpn J Clin Oncol 2011; 41: 57-62. (Among 18 patients with advance GIST tumors who were switched to sunitinib after failure of imatinib, some degree of "liver dysfunction" occurred in 26 [72%] and was grade 3-4 in 4, but details were not given). 20858619
Lee NR, Yhim HY, Yim CY, Kwak JY, Song EK. Sunitinib-induced hyperammonemic encephalopathy in gastrointestinal stromal tumors. Ann Pharmacother 2011; 45: e56. (58 year old man and 68 year old woman developed confusion 17 and 10 days after starting sunitinib for GIST [ammonia 210 and 389 μg/dL, bilirubin 1.9 and 0.7 mg/dL, ALT 50 and 53 U/L], with rapid improvement upon stopping and rapid recurrence on restarting; both patients had previously tolerated imatinib: Case 2). 21954449
Powles T, Sarwar N, Jones R, Wilson P, Boleti E, Protheroe A, Crabb SJ, et al. An indirect comparison of the toxicity of sunitinib and pazopanib in metastatic clear cell renal cancer. Eur J Cancer 2012; 48: 3171-6. (Among 77 patients given either sunitinib or pazopanib for 12 weeks before nephrectomy of renal cell cancer, raised "liver function" occurred in 9 patients [26%] on pazopanib, but none on sunitinib). 22766517
Ibrahim EM, Kazkaz GA, Abouelkhair KM, Bayer AM, Elmasri OA. Sunitinib adverse events in metastatic renal cell carcinoma: a meta-analysis. Int J Clin Oncol 2012; 18: 1060-9. (Systematic review of adverse events reported in clinical trials of sunitinib in 5658 patients wtih renal cell cancer found serum liver enzyme elevations in 40% of patients, but elevations >5 times ULN in only 3%). 23179639
Mermershtain W, Lazarev I, Shani-Shrem N, Ariad S. Fatal liver failure in a patient treated with sunitinib for renal cell carcinoma. Clin Genitourin Cancer 2013; 11: 70-2. (62 year old man with emphysema developed weakness and jaundice within 3 weeks of starting sunitinib for unresectable renal cell carcinoma [bilirubin 6.1 rising to 15.7 mg/dL, ALT 31 to 3086 U/L, LDH to 23,949 U/L, Alk P 124 U/L, INR 1.62], with progressive hypoxia, coma and death within a few days). 23063577
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; aminotransferase elevations occurred in 40-60% of patients in registration trials of sunitinib, and were above 5 times ULN in 2-5% and at least one case of severe liver injury has been reported since its approval [Weise 2009]). 23620168
Shea YF, Chiu WY, Mok MY, Hung IF, Yau CC. Sunitinib-induced hyperammonaemia in a patient with pancreatic neuroendocrine tumour. J Clin Pharm Ther 2013; 38: 327-9. (61 year old man with pancreatic neuroendocrine tumor metastatic to liver developed stupor and somnolence 2 weeks after starting sunitinib [bilirubin and INR normal, ALT 43 U/L, Alk P 196 U/L, ammonia 147 μM], resolving within 24 hours of stopping sunitinib). 23586819
Motzer RJ, Hutson TE, Cella D, Reeves J, Hawkins R, Guo J, Nathan P, et al. Pazopanib versus sunitinib in metastatic renal-cell carcinoma. N Engl J Med 2013; 369: 722-31. (Among 1110 patients with metastatic renal cell cancer treated with either pazopanib or sunitinib, overall survival was similar, but pazopanib patients had higher rates of side effects including hand-foot syndrome [50% vs 29% and ALT elevations [60% vs 43%; 17% vs 4% over 5 times ULN], and bilirubin [36% vs 27%]; no mention of clinically apparent liver injury). 23964934
Motzer RJ, Johnson T, Choueiri TK, Deen KC, Xue Z, Pandite LN, Carpenter C, Xu CF. Hyperbilirubinemia in pazopanib- or sunitinib-treated patients in COMPARZ is associated with UGT1A1 polymorphisms. Ann Oncol 2013; 24: 2927-8. (Among 1110 patients with renal cell cancer treated with tyrosine kinase inhibitors, bilirubin elevations ≥1.5 times ULN occurred in 16% on pazopanib vs 9% on sunitinib, and the accumulated rate of the elevations was higher in patients who were homozygous for the UGT1A1 polymorphisms of Gilbert syndrome). 24107802
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [6%] were attributed to antineoplastic agents including 9 to kinase inhibitors including imatinib [n=5], lapatinib [n=2] and regorafinib [n=1], but none were attributed to sunitinib). 25754159
Karczmarek-Borowska B, Sałek-Zań A. Hepatotoxicity of molecular targeted therapy. Contemp Oncol (Pozn) 2015; 19: 87-92. (Review of hepatotoxicity of modern molecular targeted therapies including monoclonal antibodies, protein kinase inhibitors and proteosome inhibitors; sunitinib has an increased risk of liver injury). 26034384
Reichardt P, Kang YK, Rutkowski P, Schuette J, Rosen LS, Seddon B, Yalcin S, et al. Clinical outcomes of patients with advanced gastrointestinal stromal tumors: safety and efficacy in a worldwide treatment-use trial of sunitinib. Cancer 2015; 121: 1405-13. (Among 1124 patients with refractory GIST treated with sunitinib in an open label worldwide treatment program, ALT elevations above 5 times ULN occurred in 2%; no mention of clinically apparent liver injury or liver failure). 25641662
Komatsu Y, Ohki E, Ueno N, Yoshida A, Toyoshima Y, Ueda E, Houzawa H, et al. Safety, efficacy and prognostic analyses of sunitinib in the post-marketing surveillance study of Japanese patients with gastrointestinal stromal tumor. Jpn J Clin Oncol 2015; 45: 1016-22. (Review of the reported hepatotoxicity of molecular targeted therapies for cancer including sunitinib and 6 other kinase inibitors ). 26373318
Eichelberg C, Vervenne WL, De Santis M, Fischer von Weikersthal L, Goebell PJ, Lerchenmüller C, Zimmermann U, et al. SWITCH: a randomised, sequential, open-label study to evaluate the efficacy and safety of sorafenib-sunitinib versus sunitinib-sorafenib in the treatment of metastatic renal cell cancer. Eur Urol 2015; 68: 837-47. (Among 365 patients with metastatic renal cell carcinoma who were switched from sorafenib to sunitinib or vice versa, response rates were similar in the two groups; ALT elevations and hepatotoxicity were not mentioned). 25952317
Shantakumar S, Nordstrom BL, Djousse L, Hall SA, Gagnon DR, Fraeman KH, van Herk-Sukel M, et al. Occurrence of hepatotoxicity with pazopanib and other anti-VEGF treatments for renal cell carcinoma: an observational study utilizing a distributed database network. Cancer Chemother Pharmacol 2016; 78: 559-66. (Review of hepatotoxicity associated with anti-VEGF treatments of renal cell cancer from two large US health care databases, highest rates of ALT elevations were found with first line treatment with pazopanib [n=180] and slightly lower rates for sorafenib [n=160], sunitinib [n=721] and bevacizumab [n=83], but clinically apparent injury with jaundice was rare [1 case with sorafenib, 2 with sunitinib]). 27438066
Guillen SS, Meijer M, de Jongh FE. Lethal acute liver failure in a patient treated with sunitinib. BMJ Case Rep 2016; 2016. (79 year old man with metastatic renal cell cancer developed acute liver and kidney injury after the 8th six week cycle of sunitinib [bilirubin [5.4 mg/dL, ALT 1844 U/L, Alk P 78 U/L, LDH 3386 U/L, prothrombin time 28 sec], with progressive liver failure and death 4 days later). 26933184
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Overview of hepatotoxicity of newer agents including tyrosine kinase inhibitors such as imatinib, bosutinib, nilotinib, ponatinib, sorafenib and sunitinib, all of which have been implicated in causing ALT and AST elevations [in 23-50% of patients] as well as clinically apparent liver injury). 27842767

## OTHER REFERENCE LINKS

1. Recent References on Sunitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Sunitinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sunitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sunitinib)